# Tumor Necrosis Factor Antagonists

## OVERVIEW

Tumor necrosis factor alpha (TNFα) is a bioactive cytokine that is an important component of inflammatory and pain pathways. Inhibition of TNFα can decrease the inflammatory response, and this approach has been used in therapy of autoimmune conditions, most effectively in inflammatory bowel disease (IBD), rheumatoid arthritis, juvenile idiopathic arthritis (also known as juvenile rheumatoid arthritis), psoriasis, psoriatic arthritis and ankylosing spondylitis. Five anti-TNF antagonists have been developed and approved for use in the United States: a mouse-human chimeric monoclonal antibody to TNFα (infliximab), two human monoclonal antibodies to TNFα (adalimumab and golimumab), a humanized Fab fragment of anti-TNFα linked to polyethylene glycol (certolizumab pegol), and a soluble recombinant fusion protein of the TNFα cellular receptor and an IgG fragment (etanercept) which on binding to tNF blocks its activity and leads to its degradation. These TNFα antagonists have potent activity in several autoimmune diseases marked by excessive production of this proinflammatory cytokine. All five of these agents are approved for use in rheumatoid arthritis and other inflammatory arthridities (psoriatic arthritis, juvenile idiopathic arthritis, and anklylosing spondylitis) and are considered “disease modifying anti-rheumatic drugs” (DMARDs), having been shown to decrease pain, improve function, and ameliorate progressive joint damage. The monoclonal antibodies to TNFα have also been shown to be effective in inflammatory bowel disease (Crohn’s disease and ulcerative colitis). In contrast, etanercept, a recombinant soluble TNFα receptor, is not effective in inflammatory bowel disease and is approved only as therapy of the inflammatory arthridities. The five TNFα antagonists appear to have similar efficacy against the rheumatic diseases but vary by indications, route of administration (intravenous vs subcutaneous) and dose regimens (every 1, 2, 4 or 8 weeks) (Table). The frequency and types of adverse side effects also vary. Generic versions (biosimilars) are available for some but not all of the TNFα antagonists and they are usually only slightly less expensive than the standard branded product.

The five TNFα antagonists cause mild to moderate serum aminotransferase elevations in a small proportion of patients (1% to 3%), and all have been linked to rare instances of clinically apparent, acute liver injury which often resembles autoimmune hepatitis and can be severe or require corticosteroid therapy. TNFα antagonists are also immunosuppressive and can lead to reactivation of latent infections such as tuberculosis and hepatitis B. Severe and even fatal instances of reactivation of hepatitis B have been linked to several anti-TNFα agents, and routine screening for HBsAg before starting therapy with these agents is recommended. Patients with HBsAg should receive prophylaxis with an oral antiviral agent during therapy with one of the TNFα antagonists.

Among the TNFα antagonists, infliximab has been most frequently linked to liver injury, including asymptomatic serum aminotransferase elevations, induction of clinically apparent autoimmune hepatitis, fulminant hepatitis, cholestatic hepatitis, vanishing bile duct syndrome, and reactivation of hepatitis B. However, the other anti-TNFα monoclonal antibodies have been less extensively studied, and liver injury of TNFα antagonists is probably class specific. For these reasons, all five of these agents should be considered potentially hepatotoxic, etanercept perhaps less so and infliximab more so than the others.

Generic Name [Yr approved] | Brand Name | Structure | Major Indications | Maintenance Dose in Adults† | Likelihood Score
Infliximab; [1998] | Remicade* | Chimeric mAb:; Anti-TNFα | RA, AS, PsA, Ps; CD, UC | 3-5 mg/kg iv; Every 8 weeks | A
Etanercept; [1998] | Enbrel | Fusion of TNFα; receptor & IgG Fc | RA, JIA, AS, PsA, Ps | 50 mg sc; Every week | B
Adalimumab; [2002] | Humira* | Human mAb:; Anti-TNFα | RA, JIA, AS, PsA, Ps, UC, CD, HD, Uveitis | 40 or 80 mg sc; Every 1 or 2 weeks | B
Certolizumab Pegol; [2008] | Cimzia | Humanized mAb:; Anti-TNFα + PEG | RA, JIA, AS, PsA, Ps, CD | 200 or 400 mg sc every 2 or 4 weeks | D
Golimumab; [2009] | Simponi | Human mAb:; Anti-TNFα | RA, AS, PsA, UC | 50 or 100 mg sc; Every 4 weeks | E*

* Biosimilars available †Different starting dose regimen ‡Data based on 2006 product labels:

Abbrevations: mAb, monoclonal antibody; TNFα, tumor necrosis factor alpha; IgG, immunoglobulin G; Fc, complement binding fraction; PEG, polyethylene glycol; RA, rheumatoid arthritis; JIA, juvenile idiopathic arthritis; PsA, psoriatic arthritis; PS, psoriasis; AS, ankylosing spondylitis; UC, ulcerative colitis; CD, Crohn disease; IBD, inflammatory bowel disease; HD, hidradenitis suppurative.

Drug Class: Antirheumatic Agents; Gastrointestinal Agents; Psoriasis Agents

Selected references on hepatotoxicity and safety of the tumor necrosis factor antagonists are given end of this Overview section. References to specific agents are provided in the drug specific sections.

The following links are to individual drug records.

1. Adalimumab

2. Certolizumab [underlined: Pegol]

3. Etanercept

4. Golimumab

5. Infliximab

## REFERENCES

References updated: 21 February 2026

Zimmerman HJ. Drugs used to treat rheumatic and musculospastic disease. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 517-54. (Expert review of hepatotoxicity published in 1999; no mention of either infliximab or etanercept).
Reuben A. Hepatotoxicity of immunosuppressive drugs. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2011, pp. 569-91. (Review of hepatotoxicity of immunosuppressive agents; "the biological immuno-suppressants are largely free from hepatototxicity, with the exception of the TNF alpha antagonists").
Wallace JL, Sharkey KA. Pharmacotherpay of inflammatory bowel disesae. In, Brunton LL, Chabner BA, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 12th ed. New York: McGraw-Hill, 2011, pp. 1350-62. (Textbook of pharmacology and therapeutics).
Maini R, St Clair EW, Breedveld F, Furst D, Kalden J, Weisman M, Smolen J, et al. Infliximab (chimeric anti-tumour necrosis factor alpha monoclonal antibody) versus placebo in rheumatoid arthritis patients receiving concomitant methotrexate: a randomised phase III trial. ATTRACT Study Group. Lancet 1999; 354: 1932-9. (Controlled trial of infliximab vs placebo for 30 weeks in 428 patients with rheumatoid arthritis receiving methotrexate, found no difference in rates of ALT elevations between the two groups [37% vs 29%] and no cases of clinically apparent liver injury). 10622295
Menghini VV, Arora AS. Infliximab-associated reversible cholestatic liver disease. Mayo Clin Proc 2001; 76: 84-6. (44 year old woman with Crohn disease developed fatigue 19 days after single infusion of infliximab with subsequent jaundice [bilirubin 7.4 rising to 19.2 mg/dL, ALT 149 U/L, Alk P 55 U/L, ANA weakly positive], liver biopsy showing bland cholestasis and abnormalities resolving within 2 months of sotpping: Case 1). 11155419
Hanauer SB, Feagan BG, Lichtenstein GR, Mayer LF, Schreiber S, Colombel JF, Rachmilewitz D, et al.; ACCENT I Study Group. Maintenance infliximab for Crohn's disease: the ACCENT I randomised trial. Lancet 2002; 359: 1541-9. (Randomized trial of infliximab vs placebo in 573 patients with Crohn disease; no mention of hepatotoxicity). 12047962
Michel M, Duvoux C, Hezode C, Cherqui D. Fulminant hepatitis after infliximab in a patient with hepatitis B virus treated for an adult onset still's disease. J Rheumatol 2003; 30: 1624-5. (Patients with adult Still disease and HBsAg [without HBeAg or HBV DNA] developed fever, rash and severe hepatitis after a second infusion of infliximab [direct bilirubin 14.6 mg/dL, ALT 30 times ULN], progressing to acute liver failure and liver transplant but without detectable HBV DNA; no testing for delta hepatitis). 12858469
Furst DE, Schiff MH, Fleischmann RM, Strand V, Birbara CA, Compagnone D, Fischkoff SA, et al. Adalimumab, a fully human anti tumor necrosis factor-alpha monoclonal antibody, and concomitant standard antirheumatic therapy for the treatment of rheumatoid arthritis: results of STAR (Safety Trial of Adalimumab in Rheumatoid Arthritis). J Rheumatol 2003; 30: 2563-71. (Controlled trial of 24 weeks of adalimumab vs placebo in 636 patients with rheumatoid arthritis; adverse events were similar between the two groups with no differences in mean ALT or AST levels; adalimumab group had higher rates of de novo autoantibody formation [ANA 27% vs 15%, anti-DNA 13% vs 1%]). 14719195
Calabrese LH, Zein N, Vassilopoulos D. Safety of antitumour necrosis factor (anti-TNF) therapy in patients with chronic viral infections: hepatitis C, hepatitis B, and HIV infection. Ann Rheum Dis 2004; 63 Suppl 2: ii18-ii24. (Review of the safety and complications of anti-TNF therapy in patients with concurrent hepatitis B or C or HIV infection). 15479865
Eriksson C, Engstrand S, Sundqvist KG, Rantapä-Dahlqvist S. Autoantibody formation in patients with rheumatoid arthritis treated with anti-TNF alpha. Ann Rheum Dis 2005; 64: 403-7. (Among 53 patients with rheumatoid arthritis treated with infliximab, ANA titers frequently increased and a proportion of patients developed anti-dsDNA while symptoms improved and rheumatoid factor titers fell). 15297281
Soto-Fernández S, González-Carro P, De Pedro-Esteban A, Legaz-Huidobro ML, Pérez-Roldán F, Roncero García Escribano O, Valbuena-González M, et al. [Infliximab-induced hepatitis in a patient with Crohn's disease]. Gastroenterol Hepatol 2006; 29: 321-2. Spanish. PMID: 16733041 (43 year old woman with Crohn disease developed asymptomatic elevations in ALT [289 U/L] after third infusion of infliximab, resolving rapidly, but more severe recurrence and symptoms upon restarting infusions 6 months later [ALT 1497 U/L, Alk P 71 U/L, bilirubin 0.6 mg/dL], resolving within a few months; all viral and autoimmune markers were negative).
Calabrese LH, Zein NN, Vassilopoulos D. Hepatitis B virus (HBV) reactivation with immunosuppressive therapy in rheumatic diseases: assessment and preventive strategies. Ann Rheum Dis 2006; 65: 983-9. (Review of the problem of reactivation of hepatitis B in patients with rheumatic diseases treated with immunosuppressive agents with recommendations on prevention). 16627542
Sandborn WJ, Feagan BG, Stoinov S, Honiball PJ, Rutgeerts P, Mason D, Bloomfield R, et al.; PRECISE 1 Study Investigators. Certolizumab pegol for the treatment of Crohn's disease. N Engl J Med 2007; 357: 228-38. (Controlled trial of certolizumab for 26 weeks in 662 adults with Crohn disease; "No clinically significant changes in laboratory values occurred in either study group"; no mention of hepatotoxicity or ALT elevations). 17634458
Tobon GJ, Cañas C, Jaller JJ, Restrepo JC, Anaya JM. Serious liver disease induced by infliximab. Clin Rheumatol 2007; 26: 578-81. (Two case reports; 39 and 54 year old women with rheumatoid arthritis developed symptoms after 8 and 17 months of infliximab therapy [bilirubin 15.2 mg/dL and not given, ALT 2560 and 291 U/L, Alk P 840 U/L and not given, ANA 1:640 and 1:160], both were treated with corticosteroids, the first required liver transplant and the second recovered). 16547695
Thiéfen G, Morelet A, Heurgué, Diebold MD, Eschard JP. Infliximab-induced hepatitis: absence of cross-toxicity with etanercept. Joint Bone Spine 2008; 75: 737-9. (48 year old man with ankylosing spondylitis developed rising ALT levels [188 to 393 to 412 U/L] and ANA [1:200 to 1:1600] after 6 infusions of infliximab, which fell to normal 3 months after stopping, and patient was then treated with etanercept for 30 months without changes in ALT levels). 18693125
Fathalla BM, Goldsmith DP, Pascasio JM, Baldridge A. Development of autoimmune hepatitis in a child with systemic-onset juvenile idiopathic arthritis during therapy with etanercept. J Clin Rheumatol 2008; 14: 297-8. (9 year old girl with juvenile idiopathic [rheumatoid] arthritis developed abdominal pain and jaundice 10 months after starting etanercept [bilirubin 12.0 mg/dL, ALT 354 U/L, GGT 388 U/L, ANA 1:640, IgG 3637 mg/dL], stopping etanercept and starting prednisone and azathioprine led to resolution, normal liver tests and negative ANA: Case 1). 18824922
Harada K, Akai Y, Koyama S, Ikenaka Y, Saito Y. A case of autoimmune hepatitis exacerbated by the administration of etanercept in the patient with rheumatoid arthritis. Clin Rheumatol 2008; 27: 1063-6. (50 year old woman with rheumatoid arthritis developed abdominal pain 2 weeks after a first injection of etanercept [bilirubin 1.2 mg/dL, ALT 300 U/L, Alk P 488 U/L, ANA 1:1280]; biopsy suggested autoimmune hepatitis and patient responded to prednisone therapy; may have had mild autoimmune hepatitis before starting therapy and also received diclofenac). 18563514
Becker H, Willeke P, Domschke W, Gaubitz M. Etanercept tolerance in a patient with previous infliximab-induced hepatitis. Clin Rheumatol 2008; 27: 1597-8. (Letter in response to Harada [2008]; 41 year old woman with seronegative rheumatoid arthritis developed elevated enzymes [ALT 1061 U/L, Alk P 244 U/L] after 3 years of infliximab therapy [ANA rising from 1:160 to 1:640], responding to stopping infliximab and prednisone therapy, later tolerating etanercept without ALT elevations and ANA levels falling to baseline). 18795397
Takeuchi T, Tatsuki Y, Nogami Y, Ishiguro N, Tanaka Y, Yamanaka H, Kamatani N, et al. Postmarketing surveillance of the safety profile of infliximab in 5000 Japanese patients with rheumatoid arthritis. Ann Rheum Dis 2008; 67: 189-94. (Among 5000 patients treated with infliximab for at least 6 months, 28% developed adverse events [6% serious], including 3.9% with hepatobiliary events [0.04% serious], but no details given). 17644554
Inman RD, Davis JC Jr, Heijde Dv, Diekman L, Sieper J, Kim SI, Mack M, et al. Efficacy and safety of golimumab in patients with ankylosing spondylitis: results of a randomized, double-blind, placebo-controlled, phase III trial. Arthritis Rheum 2008; 58: 3402-12. (Among 356 patients with ankylosing spondylitis treated with golimumab or placebo for 14 weeks, transient ALT elevations occurred in 6% of golimumab and 2.6% of placebo recipients, and were ≥2 times baseline and ≥150 U/L in 3% vs 1.3%). 18975305
Emery P, Fleischmann RM, Moreland LW, Hsia EC, Strusberg I, Durez P, Nash P, et al. Golimumab, a human anti-tumor necrosis factor alpha monoclonal antibody, injected subcutaneously every four weeks in methotrexate-naive patients with active rheumatoid arthritis: twenty-four-week results of a phase III, multicenter, randomized, double-blind, placebo-controlled study of golimumab before methotrexate as first-line therapy for early-onset rheumatoid arthritis. Arthritis Rheum 2009; 60: 2272-83. (Among 637 patients with rheumatoid arthritis treated in a randomized controlled trial, responses at 24 weeks were slightly more frequent with the combination [38%] than methotrexate alone [29%] or golimumab alone [33%], but so were ALT elevations [4.4% and 6.3% vs 1.3% and 0%]). 19644849
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J; Drug Induced Liver Injury Network (DILIN). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology 2008; 135: 1924-34. (Among 300 cases of drug induced liver disease in the US collected from 2004 to 2008, 3 were attributed to etanercept, but none to infliximab, adalimumab or certolizumab). 18955056
Burmester GR, Mease P, Dijkmans BA, Gordon K, Lovell D, Panaccione R, Perez J, et al. Adalimumab safety and mortality rates from global clinical trials of six immune-mediated inflammatory diseases. Ann Rheum Dis 2009; 68: 1863-9. (Among 19,041 patients treated with adalimumab in 36 clinical trials, serious infections occurred in 1-5 patients per year; no discussion of liver toxicity or ALT levels). 19147611
Chung SJ, Kim JK, Park MC, Park YB, Lee SK. Reactivation of hepatitis B viral infection in inactive HBsAg carriers following anti-tumor necrosis factor-alpha therapy. J Rheumatol 2009; 36: 2416-20. (Among 103 patients with rheumatoid arthritis or psoriasis treated with anti-TNF agents for 15-52 weeks, 8 were HBsAg-positive, but only 1 suffered reactivation; after third infusion with rise in ALT at week 14 peaking at 1054 U/L, HBV DNA 3.1 million copies/mL, entecavir therapy resulted in prompt improvements). 19797507
Smolen J, Landewé RB, Mease P, Brzezicki J, Mason D, Luijtens K, van Vollenhoven RF, et al. Efficacy and safety of certolizumab pegol plus methotrexate in active rheumatoid arthritis: the RAPID 2 study. A randomised controlled trial. Ann Rheum Dis 2009; 68: 797-804. (Controlled trial of methotrexate with or without certolizumab in 619 patients with rheumatoid arthritis; ALT elevations occurred in 5% of patients on methotrexate alone vs 2% on the combination; 5 cases of tuberculosis on certolizumab, but no mention of clinically apparent liver injury). 19015207
Smolen JS, Kay J, Doyle MK, Landewé R, Matteson EL, Wollenhaupt J, Gaylis N, et al.; GO-AFTER study investigators. Golimumab in patients with active rheumatoid arthritis after treatment with tumour necrosis factor alpha inhibitors (GO-AFTER study): a multicentre, randomised, double-blind, placebo-controlled, phase III trial. Lancet 2009; 374 (9685): 210-21. (Among 461 patients with rheumatoid arthritis in a 14 week randomized controlled trial, 18% on placebo vs 35% and 38% on golimumab [50 or 100 mg monthly]; no mention of ALT elevations or hepatotoxicity). 19560810
Kavanaugh A, McInnes I, Mease P, Krueger GG, Gladman D, Gomez-Reino J, Papp K, et al. Golimumab, a new human tumor necrosis factor alpha antibody, administered every four weeks as a subcutaneous injection in psoriatic arthritis: Twenty-four-week efficacy and safety results of a randomized, placebo-controlled study. Arthritis Rheum 2009; 60: 976-86. (Among 456 patients with psoriatic arthritis treated in a randomized controlled trial for 24 weeks, response rates were 48% and 51% with 50 and 100 mg of golimumab vs 9% with placebo, and rates of adverse events were similar, marked ALT elevations occurring in 0-2% of golimumab- vs 3% of placebo recipients). 19333944
Keystone EC, Genovese MC, Klareskog L, Hsia EC, Hall ST, Miranda PC, Pazdur J, et al.; GO-FORWARD Study. Golimumab, a human antibody to tumour necrosis factor {alpha} given by monthly subcutaneous injections, in active rheumatoid arthritis despite methotrexate therapy: the GO-FORWARD Study. Ann Rheum Dis 2009; 68: 789-96. (Among 444 patients with rheumatoid arthritis in a randomized controlled trial, response rates at 14 weeks were 33% with methotrexate alone, 44% with golimumab alone and 56% with the combination, and adverse events were similar in all groups; ALT elevations were not mentioned). 19066176
Shale MJ, Seow CH, Coffin CS, Kaplan GG, Panaccione R, Ghosh S. Review article: chronic viral infection in the anti-tumour necrosis factor therapy era in inflammatory bowel disease. Aliment Pharmacol Ther 2010; 31: 20-34. (Extensive review of literature on effects of anti-TNF therapies on underlying chronic hepatitis B and C; among 28 HBV-infected patients, reactivation was common in those not on antiviral therapy, more frequent with monoclonal antibodies than etanercept; among 110 HCV-infected patients, little evidence of worsening of disease and in some instances a decrease in HCV RNA levels). 19681818
Smith LS, Nelson M, Dolder CR. Certolizumab pegol: a TNF-{alpha} antagonist for the treatment of moderate-to-severe Crohn's disease. Ann Pharmacother 2010; 44: 333-42. (Review of structure, mechanism of action, pharmacology, safety and efficacy of certolizumab focusing upon Crohn disease; no mention of liver injury or ALT elevations). 20118143
Lichtenstein GR, Thomsen O ~O, Schreiber S, Lawrance IC, Hanauer SB, Bloomfield R, Sandborn WJ; Precise 3 Study Investigators. Continuous therapy with certolizumab pegol maintains remission of patients with Crohn's disease for up to 18 months. Clin Gastroenterol Hepatol 2010; 8: 600-9. (Among 241 patients with Crohn disease continued on certolizumab for up to 80 weeks, 2 patients developed tuberculosis, 1 a lupus-like syndrome, 16 [11%] ANA and 4 [2%] anti-dsDNA reactivity; no mention of liver injury or ALT elevations). 20117244
Sokolove J, Strand V, Greenberg JD, Curtis JR, Kavanaugh A, Kremer JM, Anofrei A, et al; CORRONA Investigators. Risk of elevated liver enzymes associated with TNF inhibitor utilisation in patients with rheumatoid arthritis. Ann Rheum Dis 2010; 69: 1612-7. (Retrospective analysis of ALT and AST elevations among 6861 patients with rheumatoid arthritis enrolled in a North American database receiving TNF inhibitors followed for an average of 1.5 years with ~1.7 determinations yearly; any elevation of ALT or AST occurred in 5.4% of visits, >2 times ULN in 0.6%, >5 times ULN in 0.1%; rates slightly higher for those on infliximab or when combined with methotrexate and leflunomide). 20448284
Kremer J, Ritchlin C, Mendelsohn A, Baker D, Kim L, Xu Z, Han J, et al. Golimumab, a new human anti-tumor necrosis factor alpha antibody, administered intravenously in patients with active rheumatoid arthritis: Forty-eight-week efficacy and safety results of a phase III randomized, double-blind, placebo-controlled study. Arthritis Rheum 2010; 62: 917-28. (Among 444 patients treated with golimumab with or without methotrexate or placebo and methotrexate, infections were more frequent in those who received golimumab and side effects were more frequent in those who received golimumab and methotrexate; no mention of ALT elevations or hepatotoxicity). 20131276
Which TNF inhibitor for rheumatoid arthritis? Med Lett Drugs Ther 2010; 52 (1338): 38-9. (Discussion of the efficacy, safety and costs of the 5 TNF inhibitors approved for use in rheumatoid arthritis states that none have been shown to be more effective than any other and adverse effects are similar, although reactivation of tuberculosis may be less common with etanercept than infliximab). 20467356
Vassilopoulos D, Apostolopoulou A, Hadziyannis E, Papatheodoridis GV, Manolakopoulos S, Koskinas J, Manesis EK, et al. Long-term safety of anti-TNF treatment in patients with rheumatic diseases and chronic or resolved hepatitis B virus infection. Ann Rheum Dis 2010; 69: 1352-5. (Among 131 patients with rheumatic conditions treated with anti-TNF, 14 had HBsAg [all were given prophylactic anti-HBV therapy], 19 had anti-HBs alone [from vaccination] and 19 anti-HBc [from previous infection]; during an average of 2 years of therapy, one patient with HBsAg on lamivudine developed rising titers of HBV DNA successfully treated with tenofovir, while all others had no change in serologic status or ALT levels). 20472596
Adar T, Mizrahi M, Pappo O, Scheiman-Elazary A, Shibolet O. Adalimumab-induced autoimmune hepatitis. J Clin Gastroenterol 2010; 44: e20-2. (36 year old woman with psoriasis and Crohn disease developed nausea after starting adalimumab and after 3 months liver tests were abnormal [bilirubin 0.7 mg/dL, ALT 1265 U/L, Alk P 102 U/L, ANA 1:80], resolving within 2 months of stopping therapy and starting prednisone and azathioprine). 19593165
Reuben A, Koch DG, Lee WM; Acute Liver Failure Study Group. Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology 2010; 52: 2065-76. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 were attributed to drug induced liver injury, none of which were attributed to anti-TNF agents). 20949552
Iwamoto M, Minota S. Successful treatment with very low-dose etanercept in a patient with etanercept-induced liver dysfunction. Rheumatol Int 2011; 31: 561-2. (37 year old woman with rheumatoid arthritis developed ALT elevations [peak value 165 U/L] 12 weeks after starting etanercept, 25 mg weekly, which improved on stopping but remained normal on a dose of 12.5 mg every other week). 20349067
Goldfeld DA, Verna EC, Lefkowitch J, Swaminath A. Infliximab-induced autoimmune hepatitis with successful switch to adalimumab in a patient with Crohn's disease: the index case. Dig Dis Sci 2011; 56: 3386-8. (58 year old woman with Crohn disease developed liver test abnormalities several weeks after starting infliximab [bilirubin normal, ALT ~205 U/L, ANA 1:2560], which resolved on stopping and did not recur on starting adalimumab). 21597977
Koike T, Harigai M, Inokuma S, Ishiguro N, Ryu J, Takeuchi T, Tanaka Y, et al. Postmarketing surveillance of safety and effectiveness of etanercept in Japanese patients with rheumatoid arthritis. Mod Rheumatol 2011; 21: 343-51. (Summary of 6 month postmarketing surveillance of 13,894 Japanese patients with rheumatoid arthritis treated with etanercept; adverse events were reported in 31% and were severe in 6.2%, severe reactions including pneumonia and interstitial lung disease; abnormal liver tests were reported in 328 patients [2.4%], which were severe in 15 [0.1%]). 21264488
Pérez-Alvarez R, Díaz-Lagares C, García-Hernández F, Lopez-Roses L, Brito-Zerón P, Pérez-de-Lis M, Retamozo S, et al.; BIOGEAS Study Group. Hepatitis B virus (HBV) reactivation in patients receiving tumor necrosis factor (TNF)-targeted therapy: analysis of 257 cases. Medicine (Baltimore) 2011; 90: 359-71. (Systematic review of literature identified 257 patients with preexisting HBV markers who received anti-TNF therapy, reactivation occurred in 39% of 89 patients with HBsAg [5 had acute liver failure, 4 died], but only 5% of 168 with anti-HBc without HBsAg [1 died]; lamivudine prophylaxis decreased, but did not eliminate reactivation [62% vs 23% in HBsAg carriers). 22033451
Grasland A, Sterpu R, Boussoukaya S, Mahe I. Autoimmune hepatitis induced by adalimumab with successful switch to abatacept. Eur J Clin Pharmacol 2012; 68: 895-8. (35 year old woman with seronegative arthritis developed rise in ALT [from 18 to 266 U/L, ANA 1:80, SMA 1:320] two months after starting adalimumab, which fell to normal on stopping prednisone therapy and did not recur on starting abatacept). 22205272
Vassilopoulos D, Calabrese LH. Management of rheumatic disease with comorbid HBV or HCV infection. Nat Rev Rheumatol 2012; 8: 348-57. (Clinical review of chronic hepatitis B and C and the implications in patients with rheumatic disorders with interpretation of virologic markers and recommendations for screening and prophylaxis against HBV during immunosuppressive therapy) 22565315
Titos Arcos JC, Hallal H, Robles M, Andrade RJ. Recurrent hepatotoxicity associated with etanercept and adalimumab but not with infliximab in a patient with rheumatoid arthritis. Rev Esp Enferm Dig 2012; 104: 282-4. (47 year old woman with rheumatoid arthritis developed liver test abnormalities without symptoms 2 years after starting etanercept [bilirubin not given, ALT 13 times ULN, Alk P 1.7 times ULN], resolving within 3 months of stopping, but recurring on adalimumab but not on infliximab). 22662786
Smolen JS, Kay J, Landewé RB, Matteson EL, Gaylis N, Wollenhaupt J, Murphy FT, et al. Golimumab in patients with active rheumatoid arthritis who have previous experience with tumour necrosis factor inhibitors: results of a long-term extension of the randomised, double-blind, placebo-controlled GO-AFTER study through week 160. Ann Rheum Dis 2012; 71: 1671-9. (Among 459 patients with rheumatoid arthritis in a 24 week controlled trial of golimumab, 236 were continued on treatment for up to 160 weeks; listing of adverse events did not mention ALT elevations, hepatotoxicity or reactivation of hepatitis B). 22459542
Braun J, Deodhar A, Inman RD, van der Heijde D, Mack M, Xu S, Hsu B. Golimumab administered subcutaneously every 4 weeks in ankylosing spondylitis: 104-week results of the GO-RAISE study. Ann Rheum Dis 2012; 71: 661-7. (Results of extended therapy with golimumab in patients enrolled in a previous controlled trial in ankylosing spondylitis [Inman 2009] found liver enzymes were more commonly elevated in those on 100 vs 50 mg of golimumab [5% vs 0.7%], no patient had concurrent elevation in ALT and bilirubin). 22012970
Nakayama S. Autoimmune hepatitis triggered by anti-TNF-α therapy. Case Rep Med 2013; 2013: 561748. (52 year old woman with psoriasis developed fatigue 2 months [6 doses] after starting adalimumab [bilirubin not given, ALT 424 U/L, Alk P 723 U/L, ANA 1:160, IgG 1969 mg/dL], with persistence of abnormalities leading to treatment with prednisolone with subsequent prompt improvement). 24082887
Ghabril M, Bonkovsky HL, Kum C, Davern T, Hayashi PH, Kleiner DE, Serrano J, et al.; US Drug-Induced Liver Injury Network. Liver injury from tumor necrosis factor-α antagonists: analysis of thirty-four cases. Clin Gastroenterol Hepato 2013; 11: 558-64. (Description of 6 cases of acute liver injury due to anti-TNF agents from the US included 5 women [83%], ages 28 to 54 years, onset after 2-52 weeks of treatment with infliximab [n=3], etanercept [n=2] or adalimumab [n=1], ANA present in 3, [peak bilirubin 1.5-34.2 mg/dL, ALT 384-1687 U/L, Alk P 83-1311 U/L], 5 treated with corticosteroids, but all ultimately recovered). 23333219
Björnsson ES, Bergmann OM, Björnsson HK, Kvaran RB, Olafsson S. Incidence, presentation and outcomes in patients with drug-induced liver iInjury in the general population of Iceland. Gastroenterology 2013; 144: 1419-25. (In a population based study of drug induced liver injury from Iceland, 96 cases were identified over a 2 year period, 4 of which were attributed to infliximab and one to etanercept). 23419359
Rowe BW, Gala-Lopez B, Tomlinson C, Girgis S, Shapiro JA. Fulminant hepatic failure necessitating transplantation following the initiation of infliximab therapy: a cautionary tale times two. Transpl Int. 2013; 26: e110-e112. (40 year old woman with lupus developed jaundice 4 months after starting infliximab [bilirubin 15.3 mg/dL, AST 292 U/L, Alk P 195 U/L, INR 2.6] with progressive liver failure requiring liver transplantation; 51 year old woman with ulcerative colitis developed fever and jaundice 5 months after starting infliximab [bilirubin 5.7 rising to 38.2 mg/dL, AST 568 U/L, Alk P 527 U/L, INR 2.5]). 24047326
Kim E, Bressler B, Schaeffer DF, Yoshida EM. Severe cholestasis due to adalimumab in a Crohn's disease patient. World J Hepatol 2013; 5: 592-5. (39 year old woman with Crohn disease developed jaundice 7 months after starting adalimumab and azathioprine [200 mg daily] for more than 3 years [bilirubin 9.7 mg/dL, ALT 15 U/L, Alk P 183 U/L, INR 1.8], resolving with 10 weeks of stopping both). 24179620
Sandborn WJ, Feagan BG, Marano C, Zhang H, Strauss R, Johanns J, Adedokun OJ, et al.; PURSUIT-SC Study Group. Subcutaneous golimumab induces clinical response and remission in patients with moderate-to-severe ulcerative colitis. Gastroenterology 2014; 146: 85-95. (Among 1064 adults with active ulcerative colitis given induction therapy, rates of response were 51-55% on golimumab vs 30% on placebo, and adverse events [through week 6] were similar; no mention of ALT elevations or hepatotoxicity). 23735746
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata R, A Chirino R, et al. Profile of idiosyncratic drug induced liver injury in Latin America. An analysis of published reports. Ann Hepatol 2014; 13: 231-9. (Systematic review of literature of drug induced liver injury in Latin American countries published from 1996 to 2012 identified 176 cases, the most common implicated agents being nimesulide [n=53: 30%], cyproterone [n=18], nitrofurantoin [n=17], antituberculosis drugs [n=13] and flutamide [n=12: 7%]; but none were attributed to a TNF antagonist). 24552865
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52. 25754159 (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 6 cases were attributed to TNF antagonists: 1 to adalimumab, 2 etanercept and 3 infliximab).
Shelton E, Chaudrey K, Sauk J, Khalili H, Masia R, Nguyen DD, Yajnik V, et al. New onset idiosyncratic liver enzyme elevations with biological therapy in inflammatory bowel disease. Aliment Pharmacol Ther 2015; 41: 972-9. (Among 1753 patients with inflammatory bowel disease receiving anti-TNF therapies between 2009 and 2013, 102 developed ALT elevations, but half could be attributed to another cause and the 48 attributed to infliximab [45 of 1170: 3%] or adalimumab [3 of 575: 0.5%], 34 patients [71%] recovering despite continuation of therapy, 4 stopping therapy and 10 switching to an alternative agent without suffering recurrence). 25756190
Kay J, Fleischmann R, Keystone E, Hsia EC, Hsu B, Mack M, Goldstein N, et al. Golimumab 3-year safety update: an analysis of pooled data from the long-term extensions of randomised, double-blind, placebo-controlled trials conducted in patients with rheumatoid arthritis, psoriatic arthritis or ankylosing spondylitis. Ann Rheum Dis 2015; 74: 538-46. (Analysis of 3 year results from extension studies of 5 controlled trials of golimumab in inflammatory arthritis discusses long term adverse events of serious infections, tuberculosis, opportunistic infections, demyelination syndromes and lymphoma, but not ALT elevations, hepatotoxicity or reactivation of hepatitis B). 24344160
Di Bisceglie AM, Lok AS, Martin P, Terrault N, Perrillo RP, Hoofnagle JH. Recent US Food and Drug Administration warnings on hepatitis B reactivation with immune-suppressing and anticancer drugs: just the tip of the iceberg? Hepatology 2015; 61: 703-11. (Review of the pathogenesis, clinical course, treatment and prevention of HBV reactivation in patients receiving immunosuppressive or anticancer therapies, with particular focus on rituximab and ofatumumab). 25412906
Shelton E, Chaudrey K, Sauk J, Khalili H, Masia R, Nguyen DD, Yajnik V, Ananthakrishnan AN. New onset idiosyncratic liver enzyme elevations with biological therapy in inflammatory bowel disease. Aliment Pharmacol Ther 2015; 41: 972-9. (Among 1753 patients with inflammatory bowel disease treated with anti-TNF agents, 102 [6%] developed ALT elevations, but half could be attributed to other causes; among 48 with suspected anti-TNF injury [45 infliximab, 3 adalimumab], 34 resolved spontaneously and were able to continue therapy, 10 switched to another agent without recurrence, 4 were treated with corticosteroids). 25756190
Rodrigues S, Lopes S, Magro F, Cardoso H, Horta e Vale AM, Marques M, Mariz E, et al. Autoimmune hepatitis and anti-tumor necrosis factor alpha therapy: A single center report of 8 cases. World J Gastroenterol 2015; 21: 7584-8. (Among more than 600 patients treated with anti-TNF agents over a 7 year period, 8 developed autoimmune hepatitis [7 on infliximab, 1 adalimumab]; 3 men, 5 women, most with ANA, 2 symptomatic, no mention of jaundice; all responding to corticosteroids, 2 requiring long term therapy). 26140007
Parra RS, Feitosa MR, Machado VF, Ramalho LN, da Rocha JJ, Feres O. Infliximab-associated fulminant hepatic failure in ulcerative colitis: a case report. J Med Case Rep 2015; 9: 249. (38 year old with ulcerative colitis developed liver injury after 5 doses of infliximab [ALT 408 U/L] with progression to liver failure requiring liver transplantatoin [bilirubin 23.4 mg/dL, ALT 2177 U/L, Alk P not given, INR 4.1], no mention of ANA or corticosteroid therapy). 26518665
Björnsson ES, Gunnarsson BI, Gröndal G, Jonasson JG, Einarsdottir R, Ludviksson BR, Gudbjörnsson B, Olafsson S. Risk of drug-induced liver injury from tumor necrosis factor antagonists. Clin Gastroenterol Hepatol 2015; 13: 602-8. (Among 11 cases of liver injury from anti-TNF agents identified over a 5 year period in Iceland, 9 were due to infliximab [among 1076 patients treated=1:120], 1 adalimumab [270 treated] and 1 etanercept [430 treated]; 8 women, 3 men; latency 1 to 6 months; 5 were jaundiced [peak bilirubin 0.6-7.6 mg/dL, ALT 169-1658 U/L, Alk P 71-916 U/L], 8 hepatocellular, 2 cholestatic and 1 mixed injury; 8 had ANA, 5 were treated with corticosteroids [only 1 long term], 8 were switched to another anti-TNF agent without recurrence). 25131534
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 6 cases [0.7%] were attributed to a tumor necrosis factor antagonist, including 3 to infliximab, 2 etanercept and 1 adalimumab, but none to certolizumab or golimumab). 25754159
Chiu YM, Tang CH, Hung ST, Yang YW, Fang CH, Lin HY. A real-world risk analysis of biological treatment (adalimumab and etanercept) in a country with a high prevalence of tuberculosis and chronic liver disease: a nationwide population-based study. Scand J Rheumatol 2016: 1-5. [Epub ahead of print] (Nationwide population based data on use of adalimumab [n=4049] and etanercept [n=5117] between 2007 and 2011, identified higher rates of serious hepatic events for adalimumab vs etanercept [0.75 vs 0.39 per 100 person years] as well as higher rates of tuberculosis [1.62 vs 0.57 per 100 person-years]). 27766916
Ricciuto A, Kamath BM, Walters TD, Frost K, Carman N, Church PC, Ling SC, et al. New onset autoimmune hepatitis during anti-tumor necrosis factor-alpha treatment in children. J Pediatr. 2018;194:128-135.e1. (17 year old girl with Crohn disease developed abdominal pain 23 weeks [6 infusions] after starting infliximab [bilirubin not given, ALT 359 U/L, GGT 45 U/L, ALT 1:640] resolving after stopping; and review of 659 children treated for inflammatory bowel disease with infliximab at their institution between 2000 and 2015, found ALT elevations in 8% but none developed jaundice or clinically apparent liver injury or required drug discontinuation for liver injury). 29274889
Kok B, Lester ELW, Lee WM, Hanje AJ, Stravitz RT, Girgis S, Patel V, et al; United States Acute Liver Failure Study Group. Acute liver failure from tumor necrosis factor-α antagonists: report of four cases and literature review. Dig Dis Sci. 2018;63:1654-1666. (Among more than 2500 cases of acute liver failure enrolled in a prospective US database between 1998 and 2014, 4 were attributed to infliximab induced liver injury, 3 women, 1 man, ages 34 to 59 years, with latency of 1 to 12 months, with hepatocellular pattern of enzyme elevations, 3 with ANA positivity resulting in liver transplant in 3 and death in one). 29564668
Shah P, Larson B, Wishingrad M, Nissen N, Björnsson E, Sundaram V. Now you see it, now you do not: a case of infliximab-induced vanishing bile duct syndrome. ACG Case Rep J. 2019;6:e00134. (63 year old African American man with ulcerative colitis developed jaundice 3 months after starting infliximab [bilirubin 16.0 mg/dL, ALT 1,164 U/L, Alk P 464 U/L] with progressive jaundice despite stopping [peak bilirubin 55.3 mg/dL] and biopsy showing vanishing bile duct syndrome, and requiring liver transplantation 5 weeks after onset). 31620531
Drugs for psoriatic arthritis. Med Lett Drugs Ther. 2019;61(1588):203-210. (Concise review of the mechanism of action, efficacy, safety, and costs of drugs for psoriatic arthritis, mentions that five TNF antagonists are approved for this condition and appear to have similar efficacy and their adverse events include reactivation of hepatitis B; does not mention the risk of hepatotoxicity). 31999665
Bruno CD, Fremd B, Church RJ, Daly AK, Aithal GP, Björnsson ES, Larrey D, et al. HLA associations with infliximab-induced liver injury. Pharmacogenomics J. 2020;20:681-686. (Amng 16 European patients with infliximab-induced liver injury compared to 60 matched controls, genome-wide association studies showed no apparent gene differences but imputation of HLA alleles found a higher carrier rate of B*39:01 in cases [n=4, carrier rate 25%] vs controls [none, estimated 2%). 32024945
Worland T, Chin KL, van Langenberg D, Garg M, Nicoll A. Retrospective study of idiosyncratic drug-induced liver injury from infliximab in an inflammatory bowel disease cohort: the IDLE study. Ann Gastroenterol. 2020;33:162-169. (Among 175 patients with inflammatory bowel disease treated with infliximab at a single Australian referral center, 57 developed ALT elevations, 11 were “possibly” liver injury, one was highly probable - a 60 year old man who developed ALT elevations [298 U/L] after 3 months of treatment that continued for 3 more months [ALT peak 546 U/L, bilirubin normal], falling to normal 13 weeks after stopping infliximab infusions). 32127737
Drugs for rheumatoid arthritis. Med Lett Drugs Ther. 2021;63(1637):177-184. (Concise review of the mechanism of action, efficacy, safety, and costs of drugs for rheumatoid arthritis, mentions that five TNF antagonists are indicated for rheumatoid arthritis if maximal tolerated doses of methotrexate are not adequately effective; description of adverse events mentions reactivation of hepatitis B and induction of autoimmune conditions but not hepatotoxicity). 35085210
Björnsson HK, Gudbjornsson B, Björnsson ES. Infliximab-induced liver injury: clinical phenotypes, autoimmunity and the role of corticosteroid treatment. J Hepatol. 2022;76:86-92. (Among 36 Icelandic patients who developed elevated enyzmes after starting infliximab therapy between 2009 and 2020, median age was 46 years, 78% were women, mostly with rheumatologic diseases, latency to onset median of 110 days, usually with moderate hepatocellular enzyme elevations and minimal increases in Alk P and bilirubin, only 4 with jaundice, 2 hospitalized, 67% with ANA [half were positive before therapy], infliximab stopped in all but ALT elevations frequently persisted, 17 [47%] were treated with corticosteroids which led to rapid resolution [45 vs 79 days without corticosteroids], and all eventually stopped corticosteroid without relapse even when treated with other TNF antagonists; one case presented with a cholestatic enzymes that persisted and biopsy showed paucity of bile ducts). 34487751
Eiswerth MJ, Heckroth MA, Ismail A, Gondim DD, Kaufman R. Infliximab-induced vanishing bile duct syndrome. Cureus. 2022;14:e21940. (51 year old man with melanoma developed jaundice 6 weeks after starting infliximab given for pembrolizumab-induced immune colitis [bilirubin 16.1 mg/dL, ALT 1408 U/L, Alk P 579 U/L, INR 1.0], bilirubin rising to 23.0, and liver biopsy showing cholestasis and ductopenia indicative of vanishing bile duct syndrome, treated with corticosteroids with little response). 35273881
Kashima S, Sawada K, Moriichi K, Fujiya M. A case report of drug-induced liver injury due to the infliximab biosimilar CT-P13 on switching from original infliximab in a patient with Crohn's disease. Ther Adv Drug Saf. 2022;13:20420986221100118. (23 year old Japanese woman with ulcerative colitis treated successfully with infliximab for 9 years, developed jaundice one month after switching to a biosimilar known as CT-P13 [bilirubin 8.2 mg/dL, ALT 141 U/L, Alk P 514 U/L, GGT 74 U/L, ANA negative], improved upon stopping and then tolerated restarting infliximab with clinical benefit and without recurrence of liver injury). 35646305
Björnsson ES, Stephens C, Atallah E, Robles-Diaz M, Alvarez-Alvarez I, Gerbes A, Weber S, et al. A new framework for advancing in drug-induced liver injury research. The Prospective European DILI Registry. Liver Int. 2023;43:115-126. (Initial results from the prospective European multi-national drug-induced liver injury registry [UK, Spain, Germany, Switzerland, Portugal, Iceland] describes 246 cases, the most frequent implicated agents being amoxicillin-clavulanate [12%], flucloxacillin [11%] atorvastatin [8%], nivolumab/ipilimumab [8%], infliximab [5%], nitrofurantoin [4.5%], disulfiram [2%], ibuprofen [2%], and HDS products [7.3%]; jaundice in 60% and fatal outcome in 4%) 35899490
Drugs for inflammatory bowel disease. Med Lett Drugs Ther. 2023;65(1680):105-112. (Concise review of the mechanism of action, efficacy, safety, and costs of drugs for ulcerative colitis and Crohn disease, mentions that the monoclonal antibodies to TNF are effective in induction and maintenance of remissions, infliximab and adalimumab being approved for both forms, certolizumab for ulcerative colitis only and golimumab for Crohn disease only; discussion of adverse events mentions reactivation of hepatitis B and induction of autoimmune conditions but without mention of hepatotoxicity). 37418329
Drugs for plaque psoriasis. Med Lett Drugs Ther. 2024;66(1712):153-160. (Concise review of the mechanism of action, efficacy, safety, and costs of drugs for psoriasis, mentions that four TNF antagonists are approved for moderate-to-severe plaque psoriasis and that adverse events include reactivation of hepatitis B but does not mention hepatotoxicity). 39302348
Burri E, Mangana J, Cheng PF, Schneider A, Weber A, Dummer R, Ramelyte E. Infliximab in steroid-refractory immune-related hepatitis does not demonstrate hepatotoxicity and may shorten time on steroids. J Immunother Cancer. 2024;12:e008074. (Among 10 patients with corticosteroid resistant, immune related hepatitis after monoclonal checkpoint inhibitor therapy of cancer who were then treated with infliximab, 70% had resolution within 12 to 49 days and none developed evidence of infliximab hepatotoxicity). 38969522
Bensaghir I, Tahiri L, Farih S, Rkain H, Allali F. Certolizumab-induced liver injury in ankylosing spondylitis: a case report and causality assessment. Cureus. 2024;16:e66569. (34 year old man with ankylosing spondylitis refractory to infliximab therapy developed evidence of mild liver injury 6 months after starting certolizumab [ALT 151 U/L; no mention of bilirubin or Alk P] which resolved within a month after stopping certolizumab). 39258044
Bessone F, Hernandez N, Medina-Caliz I, García-Cortés M, Schinoni MI, Mendizabal M, Chiodi D, et al. Drug-induced liver injury in Latin America: 10-year experience of the Latin American DILI (LATINDILI) Network. Clin Gastroenterol Hepatol. 2025;23:89-102.. (Among 483 cases of drug-induced liver injury enrolled in a prospective Latin American database, the mostly commonly implicated agents were amoxicillin-clavulanate [n=58,14%], anti-tuberculosis drugs [n=27, 7%], nitrofurantoin [n=20, 5%], but only one case was attributed to infliximab and none to other TNF antagonists such as etanercept, adalimumab, certolizumab, and golimumab). 38992407
Björnsson HK, Sigmundsson HK, Björnsson ES. Severe liver injury due to infliximab therapy and adalimumab. Scand J Gastroenterol. 2025;60:1238-1246. (Review of the literature identified 12 reports of severe acute liver injury due to infliximab, one of whicy required emergency liver transplantation but the remaining cases eventually recovered). 41086316
Peggie E, Shetty S, Johnston M, May C, Oien K, Kohnen G. Certolizumab-associated autoimmune-like hepatitis. BMJ Case Rep. 2025;18:e266955.. (30ish year old woman with psoriasis had a rapid clinical response certolizumab but developed enzyme elevations 10 weeks of therapy with worsening for a month after stopping [bilirubin 0.5 rising to 1.2 mg/dL, ALT 230 to 1788 U/L, Alk P 81 to 237 U/L, ANA 1:640, IgG 11.7 mg/dL] but ultimately resolving without corticosteroid therapy by 20 weeks). 41423287
Chen H, Jiang S, Wang J, Zhang A, Zhu L. Hepatobiliary disorders associated with TNF-α inhibitors: a pharmacovigilance analysis of FAERS and JADER. Front Immunol. 2026;16:1739631. (Analysis of the US FDA adverse event reporting system [FAERS] between 2004 and 2025 for TNF antagonists found 19,083 reports of hepatobiliary events, 9501 for adalimumab, 3979 infliximab, 3949 etanercept, 1012 certolizumab pegol, and 642 golimumab). 41601665